# Fosphenytoin

## OVERVIEW

### Introduction

Fosphenytoin is a prodrug of phenytoin available in parenteral forms only. While not specifically associated with cases of drug induced liver injury, fosphenytoin is converted to phenytoin which is a well known cause of acute idiosyncratic drug induced liver disease.

### Background

Fosphenytoin (fos' fen i toyn") is a hydantoin derivative that is a prodrug of phenytoin that is rapidly converted to phenytoin and is likely to have the same mechanisms of activity, efficacy and side effects as phenytoin. Phenytoin acts by stabilization of neuronal membranes through increasing the efflux and decreasing the influx of sodium ions across GABA regulated Na+ channels in neuron cell membranes. Fosphenytoin was approved for use in the United States in 1996. Current indications are for the short term treatment of tonic-clonic seizures and status epilepticus, for prevention and treatment of seizures during neurosurgery and for temporary replacement of phenytoin when oral administration is not possible. Fosphenytoin is available in parenteral formulations in 2 and 10 mL vials in concentrations of 50 mg/mL generically and under the brand name Cerebyx. The recommended dose in adults is a loading dose of 10 to 20 phenytoin sodium equivalents per kilogram intravenously initially, and then a maintenance dose of 4 to 6 equivalents per kilogram each day in divided doses. Once oral therapy can be introduced, phenytoin is usually substituted. Common adverse events include pruritus, nystagmus, dizziness, somnolence, nausea and vomiting. Rare but potentially severe adverse reactions include cardiac arrhythmias, hypotension and bradycardia with rapid infusions for which reason the infusion rate should not exceed 50 phenytoin mg equivalents per minute in adults and 2 equivalents per kilogram per minute in children. Other uncommon severe adverse reactions include hypersensitivity reactions, angioedema, DRESS and Stevens Johnson syndrome.

### Hepatotoxicity

Hepatic injury has not been specifically ascribed to use of fosphenytoin, but because it is metabolized to phenytoin, it is likely to cause similar hepatic injury. Cases of typical immunoallergic hepatitis and DRESS syndrome have been reported in patients initially treated with fosphenytoin and then converted to the oral form.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of fosphenytoin and phenytoin hepatotoxicity is not known, but is thought to be immunoallergic.

### Outcome and Management

The course and outcome of hepatotoxicity from fosphenytoin should be similar to that of phenytoin.

References on the safety and hepatotoxicity of fosphenytoin are included in the Annotated Bibliography of Phenytoin, last updated in July 2020.

Drug Class: Anticonvulsants; see also Phenytoin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fosphenytoin – Generic, Cerebyx®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fosphenytoin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fosphenytoin | 93390-81-9 | C16-H15-N2-O6-P

## OTHER REFERENCE LINKS

1 Recent References on Fosphenytoin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fosphenytoin+AND+phenytoin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fosphenytoin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fosphenytoin)